# Alpha Reductase Inhibitors

## OVERVIEW

The 5-alpha reductase inhibitors are a family of agents used to treat benign prostatic hypertrophy. They act by inhibiting the steroid 5-alpha reductase which catalyzes the conversion of testosterone to dihydrotestosterone. Dihydrotestosterone is an important prostatic growth factor and its inhibition causes gradual shrinkage of prostate. Both of the available agents lower serum concentrations of dihydrotestosterone without affecting serum testosterone and usually with minimal antiandrogenic effects.

The 5-alpha reductase inhibitors in clinical use in the United States include two agents of similar chemical structure (azasteroids) and activity: finasteride (Proscar: 1992) and dutasteride (Avodart: 2001). Both agents cause a reduction in the size of the prostate, improve urinary flow and suppress prostate-specific antigen (PSA) levels. Both finasteride and dutasteride are associated with a low rate (<1%) of serum enzyme elevations during chronic therapy, which are usually mild-to-moderate in severity, self-limited in course, and rarely require dose modification or discontinuation. Neither of the 5-alpha reductase inhibitors in current use has been linked to clinically apparent acute liver injury.

The 5-alpha reductase inhibitors used for benign prostatic hypertrophy are discussed individually, with references on their hepatotoxicity given together at the end of this introductory section.

Drug Class: Benign Prostatic Hypertrophy Agents, 5-Alpha Reductase Inhibitors

- Dutasteride
- Finasteride

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dutasteride | 164656-23-9 | C27-H30-F6-N2-O2 | Dutasteride Chemical Structure
Finasteride | 98319-26-7 | C23-H36-N2-O2 | Finasteride Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 09 January 2018

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Expert review of hepatotoxicity published in 1999; the 5-alpha reductase inhibitors are not discussed).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp 605-20. (Review of hepatotoxicity of sex hormones; the 5-alpha reductase inhibitors are not discussed).
Snyder PJ. 5-alpha reductase inhibitors. Androgens. In, Brunton LL, Chabner BA, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p 1205. (Textbook of pharmacology and therapeutics; 5-alpha reductase inhibitors include finasteride which primarily blocks the type II form of the enzyme and dutasteride which blocks both type I and II forms).
Finasteride for benign prostatic hypertrophy. Med Lett Drugs Ther 1992; 34: 83-84. (Brief summary of efficacy and safety of finasteride shortly after its approval in the US; no mention of ALT elevations or hepatotoxicity). 1380630
McConnell JD, Bruskewitz R, Walsh P, Andriole G, Lieber M, Holtgrewe HL, Albertsen P, et al. The effect of finasteride on the risk of acute urinary retention and the need for surgical treatment among men with benign prostatic hyperplasia. Finasteride Long-Term Efficacy and Safety Study Group. N Engl J Med 1998; 338: 557-63. (Controlled trial of 4 year course of finasteride vs placebo in 3040 men with symptomatic benign prostatic hypertrophy; side effects included impotence [8.1% vs 3.7%], breast tenderness and enlargement [0.5% vs 0.1%] and rash [0.5% vs 0.1%]; no mention of hepatotoxicity or ALT elevations). 9475762
Marberger MJ. Long-term effects of finasteride in patients with benign prostatic hyperplasia: a double-blind, placebo-controlled, multicenter study. PROWESS Study Group. Urology 1998; 51: 677-86. (Controlled trial of finasteride vs placebo in 3270 men treated for 2 years; side effects of finasteride were similar to placebo except for sexually related symptoms, no mention of liver injury or ALT elevations). 9610579
Dutasteride (Avodart) for benign prostatic hyperplasia. Med Lett Drugs Ther 2002; 44: 109-10. (Brief summary of efficacy and safety of dutasteride shortly after its approval in the United States; no mention of ALT elevations or hepatotoxicity). 12500154
Roehrborn CG, Boyle P, Nickel JC, Hoefner K, Andriole G; ARIA3001 ARIA3002 and ARIA3003 Study Investigators. Efficacy and safety of a dual inhibitor of 5-alpha-reductase types 1 and 2 (dutasteride) in men with benign prostatic hyperplasia. Urology 2002; 60: 434-41. (Pooled analysis of 3 trials of dutasteride in 4325 men with symptoms of benign prostatic hypertrophy showing 25% decrease in prostate size; side effects included impotence in ~5%, no mention of hepatotoxicity or ALT elevations). 12350480
Libecco JF, Bergfeld WF. Finasteride in the treatment of alopecia. Expert Opin Pharmacother 2004; 5: 933-40. (Review of chemistry, pharmacology, metabolism, efficacy for hair growth, and safety of finasteride; no mention of hepatotoxicity or ALT elevations). 15102575
Martínez de Guzmán M, Martínez-Crespo JJ. [Finasteride-induced hepatitis]. Farm Hosp 2006; 30: 385. Spanish. (Two cases of mild enzyme elevations on long term finasteride therapy for hair growth; 18 and 42 year old men with mild serum ALT elevations [78 and 71 U/L] without symptoms or jaundice, improving on stopping finasteride, one had a positive rechallenge). 17298197
Naslund MJ, Miner M. A review of the clinical efficacy and safety of 5 alpha-reductase inhibitors for the enlarged prostate. Clin Ther 2007; 29: 17-25. (Systematic review of literature on efficacy and safety of dutasteride and finasteride; similar rates of adverse events reported with each agent and were largely of sexual nature; no mention of hepatotoxicity or ALT elevations). 17379044
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to either dutasteride or finasteride). 18955056
De Nunzio C, Miano R, Trucchi A, Finazzi Agrò Tubaro A. Finasteride for prostatic disease: an updated and comprehensive review. Expert Opin Drug Metab Toxicol 2008; 4: 1561-8. (Review of pharmacology, clinical efficacy and safety of finasteride, no mention of liver injury or ALT elevations in the list of adverse events). 19040331
Keam SJ, Scott LJ. Dutasteride: a review of its use in the management of prostate disorders. Drugs 2008; 68: 463-85. (Review of chemistry, pharmacology, clinical efficacy and safety of dutasteride; "Clinical laboratory measurements were unaffected by dutasteride therapy. Abnormalities occurred in similar proportions of dutasteride or placebo recipients"). 18318566
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to dutasteride, finasteride or an agent used as therapy of benign prostatic hypertrophy). 20949552
Mella JM, Perret MC, Manzotti M, Catalano HN, Guyatt G. Efficacy and safety of finasteride therapy for androgenetic alopecia: a systematic review. Arch Dermatol 2010; 146: 1141-50. (Systematic review of safety and efficacy of finasteride [1 and 5 mg daily] in 12 studies with 3927 patients with male pattern baldness, includes discussion of sexual adverse events only). 20956649
Rossi A, Cantisani C, Scarnò M, Trucchia A, Fortuna MC, Calvieri S. Finasteride, 1 mg daily administration on male androgenetic alopecia in different age groups: 10-year follow-up. Dermatol Ther 2011; 24: 455-61. (Among 118 men with male pattern baldness treated with finasteride [1 mg daily] for up to 10 years, side effects occurred in 5.9% and were mostly related to libido, erectile function and ejaculation; no mention of severe adverse events, ALT elevations or hepatotoxicity). 21910805
Nickel JC, Gilling P, Tammela TL, Morrill B, Wilson TH, Rittmaster RS. Comparison of dutasteride and finasteride for treating benign prostatic hyperplasia: the Enlarged Prostate International Comparator Study (EPICS). BJU Int 2011; 108: 388-94. (Among 1630 men with symptomatic prostatic hypertrophy treated with either finasteride or dutasteride for 12 months of whom 448 were continued on dutasteride in an open label study for up to 3 years, adverse events were similar and largely related to sexual desire and function; no mention of hepatotoxicity or ALT elevations). 21631695
Kaplan SA, Chung DE, Lee RK, Scofield S, Te AE. A 5-year retrospective analysis of 5α-reductase inhibitors in men with benign prostatic hyperplasia: finasteride has comparable urinary symptom efficacy and prostate volume reduction, but less sexual side effects and breast complications than dutasteride. Int J Clin Pract 2012; 66: 1052-5. (Among 378 men with benign prostatic hyperplasia treated with dutasteride or finasteride for up to 5 years, side effects included loss of sexual desire and function; no mention of hepatotoxicity or ALT elevations). 23067029
Park T, Choi JY. Efficacy and safety of dutasteride for the treatment of symptomatic benign prostatic hyperplasia (BPH): a systematic review and meta-analysis. World J Urol 2014; 32: 1093-105. (Systematic review of safety and efficacy of dutasteride in controlled trials of therapy of BPH discusses symptom adverse events, but does not mention ALT elevations or hepatotoxicity). 24500194
Gubelin Harcha W, Barboza Martínez J, Tsai TF, Katsuoka K, Kawashima M, Tsuboi R, Barnes A, et al. A randomized, active- and placebo-controlled study of the efficacy and safety of different doses of dutasteride versus placebo and finasteride in the treatment of male subjects with androgenetic alopecia. J Am Acad Dermatol 2014; 70: 489-98. (Among 917 men with male pattern baldness treated with dutasteride, finasteride or placebo for 24 weeks, overall adverse events were similar and the "number of subjects with postbaseline laboratory and vital signs outside threshold values were similar across treatment groups"). 24411083
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to dutasteride or finasteride). 25754159
Yuan JQ, Mao C, Wong SY, Yang ZY, Fu XH, Dai XY, Tang JL. Comparative effectiveness and safety of monodrug therapies for lower urinary tract symptoms associated with benign prostatic hyperplasia: a network meta-analysis. Medicine (Baltimore) 2015; 94: e974. (In a metaanalysis of efficacy and safety of single agents, including finasteride and dutasteride, for relief of symptoms of benign prostatic hypertrophy, the authors conclude that "drug therapies were typically safe"; no mention of ALT elevations or hepatotoxicity). 26166130
Hirshburg JM, Kelsey PA, Therrien CA, Gavino AC, Reichenberg JS. Adverse effects and safety of 5-alpha reductase inhibitors (finasteride, dutasteride): a systematic review. J Clin Aesthet Dermatol 2016; 9: 56-62. (Systematic review of side effects of dutasteride and finasteride focusing on prostate cancer, psychiatric symptoms and sexual health in both men and women; no mention of ALT elevations or hepatotoxicity). 27672412
Tsunemi Y, Irisawa R, Yoshiie H, Brotherton B, Ito H, Tsuboi R, Kawashima M, Manyak M; ARI114264 Study Group. Long-term safety and efficacy of dutasteride in the treatment of male patients with androgenetic alopecia. J Dermatol 2016; 43: 1051-8. (Among 120 patients with alopecia treated with dutasteride for up to 1 year, adverse events inlcuded erectile dysfunction [12%] and decrease in libido [8%]; while increases in ALT levels were reported to occur, their frequency, severity and outcome were not reported). 26893187